# Duvelisib

## OVERVIEW

### Introduction

Duvelisib is an oral inhibitor of phosphatidylinositol 3-kinase (PI3K) that is approved for use in relapsed or refractory chronic lymphocytic leukemia (CLL) and small lymphocytic lymphoma (SLL). Duvelisib is associated with a high rate of serum enzyme elevations during therapy and with occasional concurrent rise in serum bilirubin and is a suspected but not proven cause of clinically apparent acute liver injury.

### Background

Duvelisib (doo" ve lis' ib) is an orally available, small molecule inhibitor of the delta and gamma isoforms of phosphatidylinositol 3-kinase (PI3K δ/λ), which is an essential component in the B cell signaling pathways that drive migration of B cells to lymph nodes and bone marrow. Inhibition of this pathway inhibits B cell chemotaxis and adherence and reduces cell viability. This pathway is upregulated in many B cell malignancies and has been shown to be critical for proliferation and survival of leukemia and lymphomatous malignant B lymphocytes. Duvelisib was approved for use in the United States in 2018 as therapy for relapsed or refractory CLL and small lymphocytic lymphoma (SLL) as well as refractory forms of follicular lymphoma (an indication that was subsequently withdrawn). Duvelisib is available as capsules of 15 and 25 mg under the brand name Copiktra. The recommended dose is 25 orally mg twice daily until disease progression or unacceptable toxicity. Side effects are common but most often mild-to-moderate in severity, and include diarrhea, neutropenia, rash, fatigue, fever, cough, musculoskeletal pain and anemia. Common laboratory abnormalities can include cytopenias, liver enzyme elevations, hyper- or hypo-glycemia, and hyponatremia. Severe adverse events (for which it has a black box warning) can include severe diarrhea or colitis, pneumonitis, intestinal perforation, severe skin rash, anaphylaxis, neutropenia and embryo-fetal toxicity.

### Hepatotoxicity

In clinical trials of duvelisib in patients with CLL and lymphoma, the rates of serum enzyme elevations during therapy ranged from 39% to 57% and were above 5 times the ULN in 3% to 8%. Serum enzyme elevations typically arose within 4 to 12 weeks of starting therapy and usually resolved rapidly with dose reduction or temporary discontinuation. In many instances, the serum aminotransferase elevations resolved spontaneously and most (but not all) patients were able to restart duvelisib without recurrence. While there were no reported cases of clinically apparent liver injury with jaundice, up to 35% of patients discontinued duvelisib because of serum enzyme elevations and all patients were followed carefully during treatment. In one study, 2% of treated patients developed concurrent elevations in serum aminotransferase and bilirubin levels but there were no episodes considered to be clinically apparent liver injury and no deaths due to liver failure. Duvelisib has not been widely used since its approval, and its potential for causing acute clinically apparent liver injury with jaundice has not been well defined. Because duvelisib affects B cell function, it may also be capable of inducing reactivation of hepatitis B, although in published trials of the agent, reactivation was not reported.

Likelihood score: E* (unproved but suspected cause of clinically apparent liver injury).

### Mechanism of Injury

The reason why duvelisib causes serum enzyme elevations is not known, but may be a direct toxicity to hepatocytes caused by inhibition of PI3K activity or the result of change in B cell activity and caused by induction of immune mediated liver injury as has been reported with other small molecule PI3K inhibitors such as idelalisib. Duvelisib is metabolized primarily in the liver by cytochrome P450 (CYP 3A4) and is susceptible to drug-drug interactions with strong inducers or inhibitors of CYP 3A4 and itself may inhibit CYP 3A4 activity and affect plasma levels of other drugs metabolized by this microsomal enzyme.

### Outcome and Management

Serum enzyme elevations are not uncommon during cancer chemotherapy with duvelisib and may occasionally be dose limiting. Duvelisib should not be used with other agents with hepatotoxic potential. Furthermore, regular monitoring of liver tests is recommended during duvelisib therapy, with more frequent monitoring if serum aminotransferase values rise. Duvelisib should be held if ALT or AST values rise above 5 times the ULN, and treatment resumed only if values fall below 3 times ULN and then with careful monitoring or at a reduced dose. Elevations of aminotransferase values of more than 20 times the ULN, or appearance of jaundice or symptoms should trigger permanent discontinuation. Corticosteroids are often used if the liver injury does not resolve rapidly with stopping duvelisib and continuing the corticosteroids may help prevent recurrence of injury with restarting therapy. There is no known cross sensitivity to hepatic injury among the different protein kinase inhibitors.

Drug Class: Antineoplastic Agents, Protein Kinase Inhibitors

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Duvelisib – Copiktra®

DRUG CLASS

Antineoplastic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Duvelisib)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Duvelisib | 1201438-56-3 | C22-H17-Cl-N6-O

## ANNOTATED BIBLIOGRAPHY

References updated: 12 July 2022

Abbreviations: CLL, chronic lymphocytic leukemia; PI3K, phosphatidylinositol 3-kinase; SLL, small cell lymphocytic lymphoma.

Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Review of hepatotoxicity published in 1999 before the availability of tyrosine kinase receptor inhibitors).
DeLeve LD. Kinase inhibitors. Cancer chemotherapy. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, p. 556. (Review of hepatotoxicity of cancer chemotherapeutic agents; does not discuss duvelisib or other PI3K inhibitors).
Wellstein A, Giaccone G, Atkins MB, Sausville EA. Pathway-targeted therapies: monoclonal antibodies, protein kinase inhibitors, and various small molecules. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1203-36. (Textbook of pharmacology and therapeutics).
FDA. https://www.accessdata.fda.gov/drugsatfda_docs/nda/2018/211155Orig1Orig2s000MultidisciplineR.pdf (FDA Drug Approvals website that has product labels [package inserts], letters of approval and full FDA scientific review of the new drug application for safety and efficacy; mentions that duvelisib has serious hepatotoxicity and that review of laboratory test results found 8 cases of concomitant elevations in ALT or AST with bilirubin that was twice normal; ALT elevations arose in 43% of treated patients and to above 5 times ULN in 8% although there were no deaths from hepatic failure).
Furman RR, Sharman JP, Coutre SE, Cheson BD, Pagel JM, Hillmen P, Barrientos JC, et al. (2014). Idelalisib and rituximab in relapsed chronic lymphocytic leukemia. N Engl J Med. (Among 220 patients with relapsed CLL treated in a placebo controlled trial, progression free survival improved with idelalisib and rituximab compared to rituximab alone, but side effects were more common with the combination including ALT or AST elevations [35% vs 19%] which were above 5 times ULN in 5% vs 1% and led to drug discontinuations in some patients, but there were no clinically apparent cases of liver injury).
Lampson BL, Kasar SN, Matos TR, Morgan EA, Rassenti L, Davids MS, Fisher DC, et al. (2016). Idelalisib given front-line for treatment of chronic lymphocytic leukemia causes frequent immune-mediated hepatotoxicity. Blood. (Among 24 patients with relapsed or refractory CLL treated with idelalisib, 19 [79%] developed ALT elevations which were above 5 times ULN in 13 [54%], usually within 28 days of starting therapy and sometimes worsening despite drug discontinuation leading to corticosteroid therapy in 16 subjects; rechallenge with idelalisib led to recurrence within a few days, but abnormalities were mild and tolerable in those on corticosteroids).
Brown JR. (2016). The PI3K pathway: clinical inhibition in chronic lymphocytic leukemia. Semin Oncol. (Review of the role of aberrant PI3K signaling in cancer with delta and lambda isoenzymes predominantly expressed in hematopoietic cells making them candidates for targeted therapy in B cell related leukemias and lymphomas).
Flinn IW, Patel M, Oki Y, Horwitz S, Foss FF, Allen K, Douglas M, et al. (2018). Duvelisib, an oral dual PI3K-δ,γ inhibitor, shows clinical activity in indolent non-Hodgkin lymphoma in a phase 1 study. Am J Hematol. (Among 31 patients with refractory, indolent non-Hodgkin lymphoma treated with 8 different doses of duvelisib, the overall response rate was 58% and dose limiting toxicities were rash and ALT or AST elevations, which arose in 57% of patients, and to above 5 times ULN in 43% with 11 dose modifications and 4 discontinuations but no instance of enzyme elevations with jaundice).
Flinn IW, Hillmen P, Montillo M, Nagy Z, Illés Á, Etienne G, Delgado J, et al. (2018). The phase 3 DUO trial: duvelisib vs ofatumumab in relapsed and refractory CLL/SLL. Blood. (Among 159 patients with relapsed or refractory CLL or SLL treated with duvelisib [25 mg twice daily] or ofatumumab [iv every 3 weeks], progression-free survival was greater with duvelisib [13.3 vs 9.9 months] and adverse reactions included diarrhea [51%], neutropenia [33%], fever [29%], nausea [23%], cough [21%], fatigue [13%], rash [10%] and ALT elevations above 5 times ULN [3%]).
O'Brien S, Patel M, Kahl BS, Horwitz SM, Foss FM, Porcu P, Jones J, et al. (2018). Duvelisib, an oral dual PI3K-δ,γ inhibitor, shows clinical and pharmacodynamic activity in chronic lymphocytic leukemia and small lymphocytic lymphoma in a phase 1 study. Am J Hematol. (Among 79 patients with CLL treated with duvelisib in multiple dose levels [8 to 75 mg twice daily] given in 28-day cycles, the overall response rate was 56% [in relapsed or refractory patients] and 83% [in treatment-naïve], and adverse events were common including ALT elevations in 31% which were above 5 times ULN in 11%).
Blair HA. (2018). Duvelisib: first global approval. Drugs. (Review of the mechanism of action, history of development, pharmacology, clinical efficacy and safety of duvelisib shortly after its approval as monotherapy for CLL and SLL; mentions that it has “manageable tolerability” and increased ALT and AST levels occur in 3% of patients).
Flinn IW, Cherry MA, Maris MB, Matous JV, Berdeja JG, Patel M. (2019). Combination trial of duvelisib (IPI-145) with rituximab or bendamustine/rituximab in patients with non-Hodgkin lymphoma or chronic lymphocytic leukemia. Am J Hematol. (Among 46 patients with relapsed or refractory non-Hodgkin lymphoma or CLL treated with duvelisib and rituximab alone or with bendamustine, the overall response rate was 72% and common adverse events were neutropenia, fatigue and rash; ALT elevations arose in 22% which were above 5 times ULN in 6.5% but there were no cases of clinically apparent liver injury with jaundice or deaths from liver disease).
Flinn IW, Miller CB, Ardeshna KM, Tetreault S, Assouline SE, Mayer J, Merli M, et al. (2019). DYNAMO: a phase II study of duvelisib (IPI-145) in patients with refractory indolent non-Hodgkin lymphoma. J Clin Oncol. (Among 129 patients with refractory or relapsing non-Hodgkin lymphoma treated with duvelisib [25 mg twice daily in 28 day cycles], the overall response rate was 47% and adverse events included diarrhea [49%], nausea [30%], neutropenia [29%], fatigue [28%], cough [27%] and ALT elevations above 5 times ULN [5.4%] but without clinically apparent liver injury).
Davids MS, Kuss BJ, Hillmen P, Montillo M, Moreno C, Essell J, Lamanna N, et al. (2020). Efficacy and safety of duvelisib following disease progression on ofatumumab in patients with relapsed/refractory CLL or SLL in the DUO crossover extension study. Clin Cancer Res. (Among 90 patients who received ofatumumab in the phase III DUO trial [Flinn 2018] who were switched to duvelisib [25 mg twice daily], 69 [77%] had an objective response while common adverse events were diarrhea [47%], neutropenia [26%], fever [24%], rash [23%] and thrombocytopenia [10%]; ALT elevations above 5 times ULN occurred in 2-3% and resulted in drug discontinuation in 1% of patients).
Ghia P, Pluta A, Wach M, Lysak D, Kozak T, Simkovic M, Kaplan P, et al. (2020). ASCEND: phase III, randomized trial of acalabrutinib versus idelalisib plus rituximab or bendamustine plus rituximab in relapsed or refractory chronic lymphocytic leukemia. J Clin Oncol. (Among 310 patients with relapsed or refractory CLL treated with acalabrutinib vs idelalisib and rituximab with or without bendamustine, the 12 month predicted progression-free survival was 88% vs 68% and serious adverse event rates were 29% vs 56% and ALT elevations above 5 times ULN arose in 1% vs 6%).
Lampson BL, Brown JR. (2021). The evolving use of phosphatidylinositol 3-kinase inhibitors for the treatment of chronic lymphocytic leukemia. Hematol Oncol Clin North Am. (Review of the mechanisms of action, clinical efficacy and safety of three PI3K inhibitors [idelalisib, duvelisib and umbralisib] as therapy of CLL, all of which were promising in early studies among refractory patients, but when used as front line therapy they had higher rates of adverse events including infections and immune mediated colitis, pneumonitis and hepatitis that were often corticosteroid responsive).
Davids MS, Fisher DC, Tyekucheva S, McDonough M, Hanna J, Lee B, Francoeur K, et al. (2021). A phase 1b/2 study of duvelisib in combination with FCR (DFCR) for frontline therapy for younger CLL patients. Leukemia. (Among 32 patients treated with duvelisib [25 mg once or twice daily] for 1 week and then with standard chemotherapy for 6 cycles, followed by duvelisib alone for up to 2 years, adverse events were frequent [94%], including thrombocytopenia [81%], neutropenia [78%], lymphopenia [77%], nausea, fatigue, fever and ALT or AST elevations above 5 times ULN in 28).

## OTHER REFERENCE LINKS

1 Recent References on Duvelisib: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Duvelisib+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Duvelisib: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Duvelisib)